# Cephalosporins

## OVERVIEW

The cephalosporins are a family of bactericidal antibiotics structurally related to penicillin which were first derived from the fungus, Cephalosporum acremonium. Their basic structure is similar to penicillin with a thiazolidine and beta-lactam ring, which has a variable side chain. Cephalosporins bind to the penicillin-binding proteins on bacteria and inhibit synthesis of the bacterial cell wall, causing cell lysis particularly in rapidly growing organisms. Their differences in activity relate to the range of penicillin-binding proteins that they inhibit. They have a broader activity than the standard penicillins, but are also sensitive to some extent to beta-lactamase. Five generations of cephalosporins have been developed with varying antibacterial activity. Cephalosporins are indicated for infections with susceptible organisms of various tissues and organs. Cephalosporins have variable oral absorption and many must be given parenterally. The oral preparations are used largely for mild and moderate infections; the parenteral forms for more severe infections and sepsis. In the lists below, formulations that are available in oral and parenteral forms are shown separately. Some of these formulations have been discontinued and are no longer available in the United States.

First generation cephalosporins include cefadroxil, cefazolin, cephalexin, and cephradine, and these are active against many gram-positive cocci, including penicillinase-producing Staphylococcus aureus.

Second generation cephalosporins include cefaclor, cefoxitin, cefprozil, cefonicid, and cefuroxime; these have broader antibacterial activity, and additional sensitive organisms including Citrobacter, Enterobacter, Haemophilus influenzae, Neisseria and Serratia species.

Third generation cephalosporins include cefdinir, cefditoren, cefixime, cefoperazone, cefotaxime, cefpodoxime, ceftazidime, ceftibuten, ceftizoxime, and ceftriaxone, which are less active than first- and second generation drugs against gram-positive bacteria, but more active against gram-negative organisms and have greater stability against beta-lactamases.

Fourth generation cephalosporins include cefepime and cefiderocol, which are active against a wide range of both gram-positive and gram-negative organisms.

Fifth generation cephalosporins include ceftaroline and ceftolozane/tazabactam, which are active against a wide range of both gram-positive and gram-negative organisms including methicillin resistant Staphylococcus aureus (MRSA). These agents are sometimes referred to as advanced generation rather than fifth generation cephalosporins.

Cephalosporins have side effects similar to penicillin, and drug-allergy and hypersensitivity are often (but not always) shared. The cephalosporins in general have been associated with little hepatotoxicity and only rare instances of drug induced liver injury due to these agents have been published. A special exception is ceftriaxone, a third generation cephalosporin which, when given parenterally, can cause biliary sludge with symptoms of cholecystitis and cholestatic jaundice. For these reasons, other than for ceftriaxone, the cephalosporins will be discussed as a general class rather than individual agents, and separately for the intravenous and oral forms.

The cephalosporins are assigned a likelihood score of causing clinically apparent liver injury as a class. Some have been implicated in only a few cases, but in general the liver injury from cephalosporins is similar from case to case. The typical case of liver injury from cephalosporins is a self-limited cholestatic hepatitis with mild if any immunoallergic features that arises 1 to 3 weeks after starting therapy, sometimes occurring after a single parenteral dose.

Below are links to overview chapters on the oral and the parenteral cephalosporins in which the specific cephalosporins are discussed together. The individual cephalosporins that have been available in the United States are also listed below, along with common brand names, whether they are available generically, and whether they have been discontinued. The generation of cephalosporin and the year that it was first approved in the United States is provided in parentheses. The only cephalosporin with a separate chapter is ceftriaxone, which has a unique clinical phenotype of liver injury (biliary sludge and stones due to crystallization of ceftriaxone in the biliary tract).

Oral Cephalosporins

- Cefaclor: Ceclor, generic (2nd: 1979)
- Cefadroxil: Duricef, generic (1st: 1978)
- Cefdinir: Omnicef, generic (3rd: 1991)
- Cefditoren: Spectracef, generic (3rd: 1994)
- Cefixime: Suprax, generic (3rd: 1989)
- Cefpodoxime: generic (3^rd^: 1989)
- Cefprozil: Cefzil, generic (2nd: 1992)
- Ceftibuten: Cedax, discontinued in 2017 (3rd: 1995)
- Cefuroxime: Ceftin, generic (2nd: 1987)
- Cephalexin: Keflex, generic (1st: 1971)
- Cephradine: Anspor, Velosef, generic, discontinued (1st: 1974)
- Loracarbef: Lorabid, discontinued in 2006 (2nd: 1991)

Parenteral Cephalosporins

- Ceftriaxone: Rocephin, generic (3rd: 1982)
- Cefazolin: Ancef, Kefzol, generic (1st: 1971)
- Cefepime: Maxipime, generic (4^th^: 1999)
- Cefiderocol: Fetroja (4th: 2019)
- Cefonicid: Monocid, discontinued in 1993 (2nd: 1984)
- Cefoperazone: Cefobid, discontinued (3rd: 1981)
- Cefotaxime: Claforan, generic (3rd: 1980)
- Cefoxitin: Mefoxin, generic (2nd: 1978)
- Ceftaroline: Teflaro (5th: 2010)
- Ceftazidime: Tazicef, generic (3rd: 1984)
- Ceftizoxime: Cefizox, discontinued in 2007 (3rd: 1994)
- Ceftolozane/Tazobactam: Zerbaxa (5th: 2014)
- Cefuroxime: Zinacef, generic (2nd: 1987)
- Cephradine: Velosef, generic, discontinued (1st: 1974)

References to both the oral and parenteral cephalosporins as well as review articles on the relative frequency of cephalosporin-related liver injury are given below rather than in the specific chapters.

## ANNOTATED BIBLIOGRAPHY

References updated: 20 December 2021

Zimmerman HJ. Cephalosporins. In, Hepatotoxicity: The adverse effects of drugs and other chemicals on the liver. 2nd Ed. Philadelphia: Lippincott, 1999. p. 589-92. (Expert review of cephalosporins and liver injury published in 1999; mentions that "cephalosporin use has been relatively free of serious hepatic injury" with rare descriptions of cholestatic injury).
Moseley RH. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd Edition. Amsterdam: Elsevier, 2013. p. 466. (Short review of cephalosporin induced liver injury mentions that hepatotoxicity from cephalosporins is rare and usually resembles penicillin induced liver injury).
Petri WA Jr. Penicillins, cephalosporins, and other ß-lactam antibiotics. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s The pharmacological basis of therapeutics, 12th ed. New York: McGraw-Hill, 2011. p. 1477-1504. (Textbook of pharmacology and therapeutics).
Fung-Herrera CG, Mulvaney WP. (1974). Cephalexin nephrotoxicity. Reversible nonoliguric acute renal failure and hepatotoxicity associated with cephalexin therapy. JAMA. (70 year old man developed nonoliguric renal failure after 8 days of cephalothin-cephalexin with mild jaundice [2.4 mg/dL, AST 85 U/L, Alk P 276 U/L], resolving within a month of stopping).
McArthur JE, Dyment PG. (1975). Stevens-Johnson syndrome with hepatitis following therapy with ampicillin and cephalexin. N Z Med J. (9 month old boy given ampicillin [developing rash 3 days after stopping] and then cephalexin [developing Stevens-Johnson after 3 days], also developed jaundice [bilirubin 13 mg/dL, ALT 460 U/L, Alk P normal], resolving with prednisone; relative role of cephalexin vs ampicillin was unclear).
Schaefer UW, Hackenberg K, Reinwein D. (1975). MMW Munch Med Wochenschr. (29 year old man developed cholestatic hepatitis [bilirubin 1.7 mg%, ALT 280 U/L, Alk P 404 U/L] after 18 days of intravenous cephalothin therapy; history of penicillin allergy [fever and rash]; hepatitis resolved within 4 weeks of stopping).
Lambert DH. (1980). Cephalosporin hepatitis. Anesth Analg. (Letter arguing that cephalosporins rather than enflurane accounted for hepatitis described by Ona et al.).
Ammann R, Neftel K, Hardmeier T, Reinhardt M. (1982). Cephalosporin-induced cholestatic jaundice. Lancet. (36 year old woman developed jaundice [bilirubin ~11.7 mg/dL, AST 6 times, Alk P 4 times ULN] after a week of cephalosporin therapy–cefazolin and cefadroxil—with slow resolution of Alk P abnormalities).
Gnann JW, Goetter WE, Elliott AM, Cobbs CG. (1982). Ceftriaxone: in vitro studies and clinical evaluation. Antimicrob Agents Chemother. (Experience in 55 adults given ceftriaxone for severe infections; cure rate of 93%; adverse events in 40%, eosinophilia in 8%, elevated enzymes in 16%, ALT 54-360 U/L, Alk P 151-400 U/L; elevations were transient and resolved with stopping).
(1983). Cholestatic jaundice and hematuria due to hypersensitivity to cefaclor in a child. J Toxicol Clin Toxicol. (4 year old boy developed hepatitis, fever and gastrointestinal upset after 8 days of oral cefaclor [bilirubin 1.7 mg/dL, ALT 270 U/L, Alk P 677 U/L, no eosinophilia or autoantibodies], which resolved ultimately but specifics on time not given).
Kanetaka T, Oda T. (1973). Toxic liver injuries. Acta Pathol Jpn. (General review of hepatotoxicity with examples, including case of cephalothin hepatotoxicity, but with few details, other than eosinophilia, fever and hyperglobulinemia; biopsy showed focal necrosis).
Døssing M, Andreasen PB. (1982). Drug-induced liver disease in Denmark: an analysis of 572 cases of hepatotoxicity reported to the Danish board of adverse reactions to drugs. Scand J Gastroenterol. (Among 572 reports of drug induced liver injury from Denmark between 1968 and 1978, representing 6% of total adverse drug reaction reports and 12% of fatal ones, cephalosporins were not mentioned as a cause).
Miller WI, Souney PF, Chang JT. (1983). Hepatic dysfunction following nafcillin and cephalothin therapy in a patient with a history of oxacillin hepatitis. Clin Pharm. (Mild ALT elevations found after 13 days of high dose oxacillin [18 g/day], similar increase after nafcillin in an injection drug user. Occurrence after cephalosporin as well, but ALT was raised an outset perhaps due to hepatitis C).
File TM, Tan JS, Salstrom SJ. (1984). Clinical evaluation of ceftriaxone. Clin Ther. (Analysis of 77 patients receiving ceftriaxone for serious infections: 93% efficacy; ALT elevations in 8 [10%, peak levels 92 U/L]).
Oakes M, MacDonald H, Wilson D. (1984). Abnormal laboratory test values during ceftriaxone therapy. Am J Med. (Analysis of laboratory test adverse events among 2,640 children and adults receiving ceftriaxone in prelicensure clinical trials; ALT elevations occurred in 3.3% vs 1.8% receiving comparative agents, but only 4 patients stopped ceftriaxone for liver test abnormalities, one of whom had clinical jaundice).
Moskovitz BL. (1984). Clinical adverse effects during ceftriaxone therapy. Am J Med. (Review of adverse effects of ceftriaxone from pre-licensure studies; 2640 patients in 153 studies, allergic reactions in 3%; jaundice in 2 patients, both septic and resolved with stopping therapy; no mention of biliary cholic).
Parry MF. (1984). Toxic and adverse reactions encountered with new beta-lactam antibiotics. Bull N Y Acad Med. (Review suggesting that hepatitis occurs in “2-5%” of cephalosporin- and penicillin treated patients).
Jacob LS, Layne P. (1984). Cefonicid: an overview of clinical studies in the United States. Rev Infect Dis. (Overview of experience with cefonicid; ALT elevations found in 1.1% of 1118 patients, but no mention of clinically apparent liver injury).
Wolf A, Schomerus H, Berg P. (1985). Z Gastroenterol. (20 year old man developed fever and jaundice [bilirubin 3.3 mg/dL, ALT 4510 U/L, Alk P 888 U/L] after 23 days of iv therapy with cefoperazone, a 3rd generation cephalosporin with accompanying renal dysfunction and gastrointestinal bleeding, recovery within 2 months of stopping).
Eggleston SM, Belandres MM. (1985). Jaundice associated with cephalosporin therapy. Drug Intell Clin Pharm. (Two patients ages 30 and 69 years developed jaundice 5 and 9 days after starting parenteral cephalosporin [cefamandole and cephapirin] therapy [bilirubin 2.2 and 6.5 mg/dL, ALT ~80 and ~20 U/L, Alk P 85 and 74 U/L]; other possible diagnoses were total parenteral nutrition jaundice, heart failure and sepsis).
Barson WJ, Miller MA, Brady MT, Powell DA. (1985). Prospective comparative trial of ceftriaxone vs. conventional therapy for treatment of bacterial meningitis in children. Pediatr Infect Dis. (Trial comparing ceftriaxone to ampicillin/chloramphenicol for meningitis in 50 children; similar efficacy, more diarrhea with ceftriaxone and 11% had minor ALT elevations, returning to normal during or after therapy).
Norrby SR. (1987). Side effects of cephalosporins. Drugs. (Clinical review of side effects of cephalosporins; ALT elevations in 1-8% and rare cases of hepatitis, usually with allergic symptoms; little evidence for cross sensitivity to hepatic damage with penicillins).
Saito A. (1989). Cefmetazole postmarketing surveillance in Japan. J Antimicrob Chemother. (Postmarketing surveys of 118,138 patients receiving cefmetazole reported adverse events in 2.1%, the most frequent being ALT elevations which arose in 839 subjects [0.7%]).
Fekety FR. (1990). Safety of parenteral third-generation cephalosporins. Am J Med. (Review article stating that ALT elevations can occur on cephalosporin therapy, but clinically apparent liver disease is rare).
Friis H, Andreasen PB. (1992). Drug-induced hepatic injury: an analysis of 1100 cases reported to the Danish Committee on Adverse Drug Reactions between 1978 and 1987. J Intern Med. (Among liver adverse drug reaction reports in Denmark between 1979 and 1987, cephalosporins not mentioned as a cause).
Thompson JW, Jacobs RF. (1993). Adverse effects of newer cephalosporins. An update. Drug Safety. (Review; transient increases in ALT, AST or Alk P occur in 0.7%, 6%, 11% and 28% of prospectively followed patients treated with various cephalosporins; clinically significant biliary sludge occurs with ceftriaxone, particularly in children, not found with other cephalosporins).
Di Martino V, Cadranel J-F, Attali P. (1994). Gastroenterol Clin Biol. (Review; despite widespread use of cephalosporins for more than 15 years, cases of hepatotoxicity are rare, variable in type and rarely severe).
Kojima N, Kumamoto I, Masumoto T, Onji M. (1994). A case report of drug-induced allergic hepatitis probably due to the N-methyltetrazolethiol group cephalosporin. Arerugi. (38 year old woman given cefpiramide for 22 days, developed jaundice 10 days later [bilirubin 13 mg/dL, ALT 920 U/L, GGT 69 U/L], resolving within 2 months of stopping; positive lymphocyte transformation test to cephalosporins with N-methyltetrazolethiol group).
Benyounes M, Horsmans Y, Galand C, Lambert M. (1995). Gastroenterol Clin Biol. (55 year old woman developed fever, rash and acute liver injury with mild jaundice [ALT 90 times and Alk P 3 times ULN, bilirubin 2.0 mg/dL] after 25 days of combination therapy with iv cephazolin and oral metronidazole, resolving 2 months after stopping).
George DK, Crawford DH. (1996). Antibacterial-induced hepatotoxicity. Incidence, prevention and management. Drug Saf. (Review of hepatotoxicity from antibiotics; liver injury from cephalosporins is extremely rare, although elevations in aminotransferases occur in 0.7-11% of treated patients).
Combe C, Banas B, Zoller WG, Manns MP, Schlöndorff D. (1996). Z Gastroenterol. (43 year old woman developed fever followed by prolonged severe cholestatic hepatitis [bilirubin 15.2 mg/dL, ALT 280 U/L, Alk P 2,075 U/L] after 3 days of ceftibuten, but also following 5 days of amoxicillin; died of pseudomonas sepsis with deep jaundice, but without vanishing bile ducts).
Pillans PI. (1996). Drug associated hepatic reactions in New Zealand: 21 years’ experience. N Z Med J. (Survey of adverse drug reaction reports found 943 causes of liver injury; cephalosporins not mentioned in the top 20 drugs during the three periods of study).
García Rodríguez LA, Ruigómez A, Jick H. (1997). A review of epidemiologic research on drug-induced acute liver injury using the general practice research data base in the United Kingdom. Pharmacotherapy. (Combined analysis of 8 epidemiologic studies using the UK General Practice Research Database estimated incidence rates of acute liver injury to be highest for isoniazid [400 per 100,000 users] and low for cephalexin [2.0 per 100,000]; only 4 cases identified).
Yossepowitch O, Amir G, Safadi R, Lossos I. (1997). Ischemic hepatitis associated with toxic epidermal necrolysis in a cirrhotic patient treated with cefuroxime. Eur J Med Res. (84 year old woman with HBV related cirrhosis developed toxic epidermal necrolysis after 1 day of cefuroxime [and gentamicin] therapy; 8 days later developed liver failure [bilirubin 7.8 mg/dL, ALT 1155 U/L, INR 2.13], autopsy showed "ischemic" necrosis; no HBV markers given).
Björnsson E, Olsson R. (1997). Acute liver injury due to loracarbef. J Hepatol. (Cholestatic hepatitis [bilirubin 19.3 mg/dL, ALT 72 U/L, Alk P 780 U/L] with severe pruritus arising 2 weeks after stopping a 4 week course of loracarbef, an oral cephalosporin, resolving within 3 months of stopping).
Longo F, Hastier P, Buckley MJ, Chichmanian RM, Delmont JP. (1998). Acute hepatitis, autoimmune hemolytic anemia, and erythroblastocytopenia induced by ceftriaxone. Am J Gastroenterol. (80 year old man developed jaundice 3 days after a 12-day course of oral ceftriaxone, [bilirubin 22 times, ALT 11 times and Alk P 6 times ULN], followed by severe hemolytic anemia during recovery requiring prednisone and resolving only by 6 months after stopping).
Famularo G, Bizzarri C, Federico M, et al. (2001). Eosinophilic hepatitis associated with cefonicid therapy. Ann Pharmacother. (67 year old man developed nausea and abdominal pain 14 days after starting cefonicid therapy [bilirubin normal, ALT 312 U/L, Alk P 563 U/L, eosinophils 22%], resolving within 1-8 weeks of stopping).
Sgro C, Clinard F, Ouazir K, Chanay H, Allard C, Guilleminet C, Lenoir C, et al. (2002). Incidence of drug-induced hepatic injuries: a French population-based study. Hepatology. (All adverse drug reactions from French region from 1997-2000 found 34 cases of liver injury,–2 deaths–for an incidence of 14/100,000, none related to a cephalosporin).
Skoog SM, Smyrk TC, Talwalkar JA. (2004). Cephalexin-induced cholestatic hepatitis. J Clin Gastroenterol. (51 year old man received single infusion of cefazolin preoperatively for Achilles tendon repair, followed 2 weeks later by 10 day course of cephalexin and had onset of dark urine within 3 days eventually developing fever, hives and jaundice [bilirubin 17.9 mg/dL, ALT 87 U/L, Alk P 272 U/L], resolving within 2-3 months of stopping).
Köklü S, Yüksel O, Yolcu OF, Arhan M, Altiparmak E. (2004). Cholestatic attack due to ampicillin and cross-reactivity to cefuroxime. Ann Pharmacother. (Follow-up on previous report of liver injury from ampicillin, 23 year old man redeveloped liver injury 17 days after starting a 10 day course of oral cefuroxime [bilirubin 0.7 mg/dL, ALT 427 U/L, Alk P 646 U/L], resolving within 2 months; suggesting cross reactivity with ampicillin).
Ravisha MS, Godambe SV. (2004). Ceftriaxone induced cholestasis in a neonate: a case report. Indian J Med Sci. (17 year old boy developed cholestasis after 7 days of iv ceftriaxone; sludge on ultrasound [bilirubin 2.6 mg/dL, ALT 98 U/L, Alk P 1194 U/L], resolving within 3-7 days).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but no case was attributed to a cephalosporin).
de Abajo FJ, Montero D, Madurga M, García Rodríguez LA. (2004). Acute and clinically relevant drug-induced liver injury: a population based case-control study. Br J Clin Pharmacol. (Analysis of General Practice Research Database from UK on 1.6 million persons from 1994-2000 found 128 cases of drug induced liver injury (2.4/100,000 person years); 2 occurred in patients receiving cephalosporins, but other agents were being taken and the adjusted odds ratio for risk of hepatotoxicity was not significantly elevated for cephalosporins).
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. (2005). Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol. (Survey of all cases of DILI with fatal outcome from Swedish Adverse Drug Reporting system from 1966-2002; 103 cases identified as highly probable, probable or possible; no case was attributed to a cephalosporin).
Bell MJ, Stockwell DC, Luban NL, et al. (2005). Ceftriaxone-induced hemolytic anemia and hepatitis in an adolescent with hemoglobin SC disease. Pediatr Crit Care Med. (17 year old boy with sickle cell disease and severe hemolytic anemia given ceftriaxone developed progressive renal and hepatic failure and death; liver failure likely due to shock).
Rivkin AM. (2005). Hepatocellular enzyme elevations in a patient receiving ceftriaxone. Am J Health Syst Pharm. (Case report and literature review; seriously ill 31 year old man in ICU had increase in ALT from 9 to 56 to 442 U/L, but normal Alk P and bilirubin and no symptoms, after 7 days of ceftriaxone therapy, with resolution within 2 weeks of switching antibiotics).
Bilici A, Karaduman M, Cankir Z. (2007). A rare case of hepatitis associated with cefprozil therapy. Scand J Infect Dis. (15 year old girl developed jaundice 1 week after finishing a 10 day course of cefprozil [bilirubin 3.5 mg/dL, ALT 543 U/L, Alk P 247 U/L], resolving within 4 weeks).
Pacik PT. (2007). Augmentation mammaplasty: postoperative cephalosporin-induced hepatitis. Plast Reconstr Surg. (Three patients developed postoperative hepatitis 2-3 weeks after augmentation mammaplasty having received a single dose of cephazolin intraoperatively, no details given).
Talbot GH, Thye D, Das A, Ge Y. (2007). Phase 2 study of ceftaroline versus standard therapy in treatment of complicated skin and skin structure infections. Antimicrob Agents Chemother. (Among 100 patients with complicated skin or skin structure infections treated with intravenous ceftaroline vs vancomycin with or without aztreonam, clinical cure rates and adverse event rates were similar; ALT elevations occurring in 6% vs 12.5% of patients, but no instance of clinically apparent liver injury).
Chen J, Ahmad J. (2008). Cefdinir-induced hepatotoxicity: potential hazards of inappropriate antibiotic use. J Gen Intern Med. (22 year old man developed jaundice shortly after a 10 day course of cefdinir [bilirubin 15.7 rising to 41.4 mg/dL, ALT 96 U/L, Alk P 175 U/L], slow, but eventual recovery 7 weeks later).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 5 cases were attributed to cephalosporins with single cases linked to cefaclor, cephalexin, cefazolin cefuroxime and ceftriaxone).
Peker E, Cagan E, Dogan M. (2009). Ceftriaxone-induced toxic hepatitis. World J Gastroenterol. (12 year old boy developed fatigue after 3 days of ceftriaxone therapy followed by jaundice [bilirubin 4.2 mg/dL, ALT 871 U/L, Alk P 143 U/L, 8% eosinophils], resolving within 10 weeks of stopping).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, 104 of which were attributed to ceftriaxone, ranking 10th in frequency and being the only cephalosporin listed).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, one of which was attributed to cefepime, but none to ceftriaxone or other cephalosporins).
Ekiz F, Usküdar O, Simsek Z, Yüksel I, Basar O, Altinbas A, Yüksel O. (2010). Cefuroxime axetil-induced liver failure. Ann Hepatol. (60 year old woman developed jaundice 4 days after a 10 day course of oral cefuroxime [bilirubin 17.9 rising to 30 mg/dL, ALT 1527 U/L, Alk P 1006 U/L], with progressive worsening of INR [1.9] and referral for transplantation, but subsequent full recovery).
Corey GR, Wilcox M, Talbot GH, Friedland HD, Baculik T, Witherell GW, Critchley I, et al. (2010). Integrated analysis of CANVAS 1 and 2: phase 3, multicenter, randomized, double-blind studies to evaluate the safety and efficacy of ceftaroline versus vancomycin plus aztreonam in complicated skin and -structure infection. Clin Infect Dis. (Among 1378 patients with complicated skin or skin structure infections treated with ceftaroline or vancomycin with aztreonam in two large controlled trials, clinical cure rates were similar; no mention of ALT elevations or liver related adverse events).
File TM, Low DE, Eckburg PB, Talbot GH, Friedland HD, Lee J, Llorens L, et al. (2010). Integrated analysis of FOCUS 1 and FOCUS 2: randomized, doubled-blinded, multicenter phase 3 trials of the efficacy and safety of ceftaroline fosamil versus ceftriaxone in patients with community-acquired pneumonia. Clin Infect Dis. (Among 1228 patients with community acquired bacterial pneumonia treated with ceftaroline or ceftriaxone in two controlled trials, clinical cure rates were similar as were rates of adverse events overall; there were no differences in rates of abnormal laboratory results).
(2011). Ceftaroline fosamil (Teflaro) – a new IV cephalosporin. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of ceftaroline shortly after its approval as therapy of complicated skin and skin structure infections and community acquired pneumonia in the US, mentions common side effects as being diarrhea, nausea, rash and direct Coombs test positivity, and rare complications of C. difficile infection, but does not mention ALT elevations or hepatotoxicity).
Kaur I, Singh J. (2011). Cholestatic hepatitis with intravenous ceftriaxone. Indian J Pharmacol. (24 year old woman developed dark urine 24 hours after starting ceftriaxone and piroxicam and 3 days later was jaundiced [bilirubin 6.5 mg/dL, ALT 164 U/L, Alk P 580 U/L], resolving within 3 weeks of stopping both drugs).
Yilmaz B, Ekız F, Coban S, Yüksel I, Yüksel O. (2011). Cefixime-induced hepatotoxicity. Turk J Gastroenterol. (50 year old woman developed anorexia and abdominal pain 5 days after completing a 7-day course of oral cefixime [ALT 156 U/L, GGT 281 U/L, bilirubin, Alk P and INR normal], resolving within 2 weeks of onset).
Choi YY, Jung YH, Choi SM, Lee CS, Kim D, Hur KY. (2011). Gallbladder pseudolithiasis caused by ceftriaxone in young adult. J Korean Surg Soc. (Two men, ages 21 and 22 years, developed gallstones found by CT scan 5 and 17 days after starting ceftriaxone without symptoms or laboratory abnormalities, resolving within 1 month of stopping).
Kwon H, Lee SH, Kim SE, Lee JH, Jee YK, Kang HR, Park BJ, et al. (2012). Spontaneously reported hepatic adverse drug events in Korea: multicenter study. J Korean Med Sci. (Summary of 2 years of adverse event reporting in Korea; of 9360 reports, 567 were liver related, including 54 [9.5%] attributed to cephalosporins, but no details provided).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, of which 2 were attributed to cephalosporins, one with jaundice to cephalexin and one with enzyme elevations only to ceftazidime).
Rodríguez Rangel DA, Pinilla Orejarena AP, Bustacara Diaz M, Henao García L, López Cadena A, Montoya Camargo R, Moreno LA. (2014). An Pediatr (Barc). (Prospective study in 73 children receiving ceftriaxone, identified sludge or gallstones [4-14 mm in diameter] by ultrasound in 31 [43%], of whom 7 had symptoms, all resolving within 2 months of stopping, but one requiring surgery).
Tomoda T, Ueki T, Saito S, Tatsukawa M, Nawa T, Hamamoto H, Endo H, Yabushita K, Shimoe T, Sakaguchi K. (2013). Nihon Shokakibyo Gakkai Zasshi. (47 year old woman found to have developed biliary stones and sludge on CT scan after 8 days of intravenous ceftriaxone, which disappeared within 6 days).
von Martels JZ, Van de Meeberg EK, Holman M, Ligtenberg JJ, Ter Maaten JC. Pseudolithiasis after recent use of ceftriaxone: an unexpected diagnosis in a child with abdominal pain. Am J Emerg Med 2013; 31: 1294. e5-6. (14 year old boy treated for Lyme disease with a 2 week course of iv ceftriaxone presented 4 days later with abdominal pain and biliary stones by ultrasound and ERCP [bilirubin 4.2 mg/dL, ALT 187 U/L, Alk P 398, GGT 291 U/L], resolving with conservative management within a few days and no stones found on follow-up ultrasound 4 weeks later).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, but none were attributed to a cephalosporin).
Alemayehu H, Desai AA, Thomas P, Sharp SW, St Peter SD. (2014). Ceftriaxone-induced pseudolithiasis in children treated for perforated appendicitis. Pediatr Surg Int. (Among 71 children treated with iv ceftriaxone for perforated appendicitis, 10 [14%] developed gallbladder stones or sludge, one of whom developed symptoms and underwent cholecystectomy).
Lucasti C, Hershberger E, Miller B, Yankelev S, Steenbergen J, Friedland I, Solomkin J. (2014). Multicenter, double-blind, randomized, phase II trial to assess the safety and efficacy of ceftolozane-tazobactam plus metronidazole compared with meropenem in adult patients with complicated intra-abdominal infections. Antimicrob Agents Chemother. (Among 121 patients with complicated intra-abdominal infections enrolled in a controlled trial, clinical cure rates were lower with ceftolozane with tazobactam [84%] than meropenem [96%], but adverse event rates were similar [50% vs 49%], ALT elevations occurring in no patient on ceftolozane but 8% on meropenem).
Casapao AM, Davis SL, Barr VO, Klinker KP, Goff DA, Barber KE, Kaye KS, et al. (2014). Large retrospective evaluation of the effectiveness and safety of ceftaroline fosamil therapy. Antimicrob Agents Chemother. (Among 527 patients treated with ceftaroline in a retrospective survey from 5 medical centers, clinical response rates were high [88%] and adverse events were uncommon and usually mild, only one patient [<1%] having had a transient ALT elevation).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: the DILIN prospective study. Gastroenterology. (Among 899 cases of drug induced liver injury seen over a ten year period at 8 U.S. medical centers, 323 [36%] were attributed to antibiotics of which 36 [4%] were cephalosporins including cefazolin [21], ceftriaxone [4], cefalexin [3], cefadroxil [2] and cefuroxime [2] and four others [1 case each]).
Alqahtani SA, Kleiner DE, Ghabril M, Gu J, Hoofnagle JH, Rockey DC, Drug-Induced Liver Injury Network (DILIN) Study Investigators. (2015). Identification and characterization of cefazolin-induced liver injury. Clin Gastroenterol Hepatol. (Among 1019 patients enrolled in a US database of drug induced liver injury between 2004 and 2012, 33 [3%] were due to cephalosporins, of which 19 presented 6-29 days after a single iv injection of cefazolin exhibiting a cholestatic pattern of injury, mild immunoallergic features, moderate severity and invariably a self-limited course).
Wagenlehner FM, Umeh O, Steenbergen J, Yuan G, Darouiche RO. (2015). Ceftolozane-tazobactam compared with levofloxacin in the treatment of complicated urinary-tract infections, including pyelonephritis: a randomised, double-blind, phase 3 trial (ASPECT-cUTI). Lancet. (Among 1083 patients with complicated urinary tract infections treated with intravenous ceftolozane with tazobactam or levofloxacin for 7 days, clinical cure rates were higher with ceftolozane [77% vs 68%], while overall adverse event rates were similar [35% vs 34%] and ALT elevations occurred in 1.7% vs 0.9%, but there were no liver related serious adverse events or discontinuations).
Solomkin J, Hershberger E, Miller B, Popejoy M, Friedland I, Steenbergen J, Yoon M, et al. (2015). Ceftolozane/tazobactam plus metronidazole for complicated intra-abdominal infections in an era of multidrug resistance: results from a randomized, double-blind, phase 3 trial (ASPECT-cIAI). Clin Infect Dis. (Among 596 patients with complicated intra-abdominal infections treated with ceftolozane/tazobactam or meropenem with metronidazole, clinical cure rates were similar [83% vs 87%], as were overall adverse events rates [44% vs 43%] with ALT elevations in 2.5% of patients; no mention of liver related serious adverse events).
(2015). Ceftolozane/Tazobactam (Zerbaxa)--a new intravenous antibiotic. Med Lett Drugs Ther. (Concise summary of the mechanism of action, clinical efficacy, side effects and costs of ceftolozane with tazobactam shortly after its approval for complicated urinary tract or intrabdominal infections in the US; mentions common side effects as being diarrhea, nausea, headache and fever and rare but serious adverse events of C. difficile colitis and hypersensitivity reactions; no mention of ALT elevations or hepatotoxicity).
Khurram D, Shamban L, Kornas R, Paul M. (2015). Marked direct hyperbilirubinemia due to ceftriaxone in an adult with sickle cell disease. Case Rep Gastrointest Med. (32 year old African American man with sickle cell disease during admission for an acute crisis and ceftriaxone and azithromycin therapy for suspected pneumonitis, had rise in total bilirubin levels from 3.3 to a peak of 17 mg/dL, which fell to baseline on switching antibiotics and resolution of the acute crisis; no direct bilirubin levels provided but increase was likely due to hemolysis and sepsis).
Dryden M, Zhang Y, Wilson D, Iaconis JP, Gonzalez J. (2016). A Phase III, randomized, controlled, non-inferiority trial of ceftaroline fosamil 600 mg every 8 h versus vancomycin plus aztreonam in patients with complicated skin and soft tissue infection with systemic inflammatory response or underlying comorbidities. J Antimicrob Chemother. (Among 761 patients with complicated skin and skin structure infections treated with intravenous ceftaroline or vancomycin with aztreonam, clinical cure rates were similar [78% vs 79%] as were adverse event rates, which included ALT elevations in 1.2% vs 1.6%, but no liver related serious adverse events).
Korczowski B, Antadze T, Giorgobiani M, Stryjewski ME, Jandourek A, Smith A, O'Neal T, et al. (2016). A multicenter, randomized, observer-blinded, active-controlled study to evaluate the safety and efficacy of ceftaroline versus comparator in pediatric patients with acute bacterial skin and skin structure infection. Pediatr Infect Dis J. (Among 159 children with acute bacterial skin and skin structure infections treated with intravenous ceftaroline or comparator antibiotics, clinical cure rates were similar as were adverse events including clinical chemistry abnormalities; ALT elevations above 3 times ULN occurred in 1% on ceftaroline and 2% on comparator agents [1 patient in each group]).
Niriella MA, Kumarasena RS, Dassanayake AS, Pathirana A, de Silva HJ. (2016). Worsening cholestasis and possible cefuroxime-induced liver injury following "successful" therapeutic endoscopic retrograde cholangiopancreatography for a distal common bile duct stone: a case report. J Med Case Rep. (51 year old man with jaundice underwent ERCP and extraction of gallstones from the common bile duct and was treated with cefuroxime for 5 days but cholestatic injury worsened [bilirubin 6.4 rising to 48 mg/dL, ALT 381 decreasing to 65 U/L, Alk P 318 rising to 901 U/L, INR 1.1], liver biopsy showing severe cholestasis but no bile duct loss, eventually recovering although Alk P remained mildly elevated).
Nakaharai K, Sakamoto Y, Yaita K, Yoshimura Y, Igarashi S, Tachikawa N. (2016). Drug-induced liver injury associated with high-dose ceftriaxone: a retrospective cohort study adjusted for the propensity score. Eur J Clin Pharmacol. (Retrospective analysis of 471 patients treated with ceftriaxone found that 15 [3.2%] developed abnormal liver tests within two weeks of treatment, including 16% receiving high dose [4 g daily] vs 2.1% receiving standard dose [2 g daily]).
Bonkovsky HL, Kleiner DE, Gu J, Odin JA, Russo MW, Navarro VM, Fontana RJ, et al., U.S. Drug Induced Liver Injury Network Investigators. (2017). Clinical presentations and outcomes of bile duct loss caused by drugs and herbal and dietary supplements. Hepatology. (Among 26 patients with drug induced liver injury and bile duct loss on liver biopsy, most developed severe cholestatic hepatitis an evidence of chronic residual liver injury suggestive of varying degrees of vanishing bile duct syndrome, one case was attributed to oral cephalexin and one to parenteral cefazolin).
Ferrajolo C, Verhamme KM, Trifirò G, 't Jong GW, Picelli G, Giaquinto C, Mazzaglia G, et al. (2017). Antibiotic-induced liver injury in paediatric outpatients: a case-control study in primary care databases. Drug Saf. (Among 938 cases of drug-associated liver injury in children identified in Italian and Dutch databases [with 93,665 controls] between 2000 and 2008, 138 arose after recent use of antibiotics including 26 linked to cephalosporins; cefaclor [n=8], cefixime [8], ceftriaxone [3], ceftibuten [3], cefpodoxime [2] and cefuroxime [1], the highest risk odds ratio being for ceftriaxone [14.7] and cefixime [6.1]).
Björnsson ES. (2017). Drug-induced liver injury due to antibiotics. Scand J Gastroenterol. (Review of antibiotic induced liver injury, which accounts for at least 30% of drug induced causes, typically due to amoxicillin/clavulanate [~12%] but also nitrofurantoin, fluoroquinolones and cephalosporins [~1%]; cephalosporins typically causing cholestatic hepatitis 7-21 days after starting and sometimes after a single iv dose; the incidence of injury may vary by specific agent, studies from Iceland suggesting a rate of 1:5206 treated patients for cephalexin and 1:278 for ceftazidime).
Zhao Z, Bao L, Yu X, Zhu C, Xu J, Wang Y, Yin M, et al. (2017). Acute vanishing bile duct syndrome after therapy with cephalosporin, metronidazole, and clotrimazole: A case report. Medicine (Baltimore). (27 year old woman was treated with “cephalosporin”, metronidazole and clotrimazole after removal of an intrauterine device and developed evidence of liver injury several weeks later [bilirubin 1.7 mg/dL, ALT 335 U/L, Alk P 655 U/L], with persistence of jaundice for several months and liver biopsy showing paucity of bile ducts, but ultimate resolution of jaundice but persistence of mild Alk P elevations).
Munz M, Grummich H, Birkmann J, Wilhelm M, Holzgrabe U, Sörgel F. (2017). Severe drug-induced liver injury as an adverse drug event of antibiotics: a case report and review of the literature. Chemotherapy. (20 year old woman treated with multiple antibiotics including cefazolin developed jaundice 3 weeks later [bilirubin 3.7 rising to 16.9 mg/dL, ALT 1219 U/L, Alk P 143 U/L, INR 1.57 rising to 2.62], listed for liver transplant, but ultimately had a spontaneous recovery).
Gupta A, Singh AK, Faridi K, Jain P. (2018). Cefazolin induced liver injury and hypoprothrombinemia. J Clin Exp Hepatol. (6 year old male with medulloblastoma developed acute hepatic necrosis within 4 days of starting cefazolin in preparation for surgery [bilirubin 3.1 mg/dL, ALT 4360 U/L, GGT 109 U/L, INR 10.3], with rapid improvement on stopping cefazolin and giving vitamin K).
Portsmouth S, van Veenhuyzen D, Echols R, Machida M, Ferreira JCA, Ariyasu M, Tenke P, et al. (2018). Cefiderocol versus imipenem-cilastatin for the treatment of complicated urinary tract infections caused by Gram-negative uropathogens: a phase 2, randomised, double-blind, non-inferiority trial. Lancet Infect Dis. (Among 448 patients with complicated urinary tract infections or pyelonephritis caused by carbapenem-resistant gram-negative organisms treated with cefiderocol [2 g] or imipenem-cilastatin [1 g each] for 7 to 14 days, a clinical cure was achieved in 73% vs 55% and adverse events arose in 41% vs 57% of patients including ALT elevations above 5 times ULN in 1.0% vs 0.7%]).
Liao PF, Wu YK, Huang KL, Chen HY. (2019). A rare case of cefepime-induced cholestatic liver injury. Ci Ji Yi Xue Za Zhi. (93 year old man with severe pneumonia developed a cholestatic hepatitis having received multiple antibiotics including cefuroxime, ceftazidime and cefepime [bilirubin 9.5 mg/dL, ALT 86 U/L, Alk P 515 U/L, INR normal], with resolution of bilirubin elevations within 4 weeks of stopping).
Fotoulaki M, Giza S, Jirsa M, Grammatikopoulos T, Miquel R, Hytiroglou P, Tsitouridis I, et al. (2019). Beyond an obvious cause of cholestasis in a toddler: compound heterozygosity for ABCB11 Mutations. Pediatrics. (27 month old female developed jaundice after receiving a 10 day course of cefprozil [bilirubin 19 mg/dL, ALT 46 U/L, GGT 7 U/L] and was found to have recurrences of jaundice and a heterozygosity of two mutations associated with neonatal cholestasis).
Zhanel GG, Golden AR, Zelenitsky S, Wiebe K, Lawrence CK, Adam HJ, Idowu T, et al. (2019). Cefiderocol: a siderophore cephalosporin with activity against carbapenem-resistant and multidrug-resistant gram-negative bacilli. Drugs. (Review of the mechanism of action, pharmacology, clinical efficacy and safety of cefiderocol, a unique cephalosporin which binds iron [siderophore] and has high stability to beta-lactamases and potent activity against carbapenem-resistant strains of Actinetobacter, Klebsiella and Pseudomonas).
Low EXS, Zheng Q, Chan E, Lim SG. (2020). Drug induced liver injury: East versus West – a systematic review and meta-analysis. Clin Mol Hepatol. (Analysis of literature on causes of drug induced liver injury found that the most common causes from Asian reports were anti-tuberculosis drugs [25%], phenytoin [3.5%], and cephalosporins [3%] while the most common causes from European and American reports were amoxicillin/clavulanate [11%], nimesulide [6%], and ibuprofen [6%]).
(2020). Cefiderocol (Fetroja) – a new intravenous cephalosporin for complicated UTI. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and relative costs of cefiderocol in relation to other parenteral antibiotics used to treat complicated urinary tract infections, mentions that transient serum aminotransferase elevations have been reported in patients receiving cefiderocol).
Wunderink RG, Matsunaga Y, Ariyasu M, Clevenbergh P, Echols R, Kaye KS, Kollef M, et al. (2021). Cefiderocol versus high-dose, extended-infusion meropenem for the treatment of Gram-negative nosocomial pneumonia (APEKS-NP): a randomised, double-blind, phase 3, non-inferiority trial. Lancet Infect Dis. (Among 300 patients with gram negative nosocomial pneumonia treated with cefiderocol [2 g] or meropenem [2 g] every 8 hours for at least 5 days, all-cause mortality at 14 days [12% vs 12%] and cure rates [65% vs 67%] were similar in the two groups as were total and severe adverse event rates, while ALT elevations were uncommon [6.1% vs 4.0%] and severe enzyme elevations rare [0.7% vs 2.7%]).
Bassetti M, Echols R, Matsunaga Y, Ariyasu M, Doi Y, Ferrer R, Lodise TP, et al. (2021). Efficacy and safety of cefiderocol or best available therapy for the treatment of serious infections caused by carbapenem-resistant Gram-negative bacteria (CREDIBLE-CR): a randomised, open-label, multicentre, pathogen-focused, descriptive, phase 3 trial. Lancet Infect Dis. (Among 203 patients with gram negative, carbapenem-resistant severe nosocomial infections treated with cefiderocol or best available treatment, cure rates were similar [66% vs 58%] and adverse event rates were frequent but were severe and related in only 1% vs 10%, although liver related adverse events were more frequent with cefiderocol [30% vs 14%] and ALT elevations led to early discontinuation in 1 patient).
Park JH, Hong S, Jun DW, Yoon JH, Lee KN, Lee HL, Lee OY, et al. (2021). Prevalence and clinical characteristics of antibiotics associated drug induced liver injury. Ann Transl Med. (Among 166 patients seen at a single Korean medical center over a 12 month period [2017-18] for serum enzyme elevations, 113 were attributed to drugs, including 78 [64%] to antibiotics, most frequently flomoxef [a cephalomycin, n=24], cetrazole [9], ceftriaxone [6], vancomycin [5], piperacillin-tazobactam [5], and amoxicillin/clavulanate [4], all of whom recovered upon stopping; unclear whether any were symptomatic or jaundiced).
Shah T, Joslyn JA, Lai J. (2021). Ceftazidime induced liver injury. BMJ Case Rep. (65 year old woman with diabetes and osteomyelitis developed liver test abnormalities one day after starting ceftazidime having also received amoxicillin/clavulanate [bilirubin 0.4 mg/dL, ALT 891 U/L, Alk P 491 U/L, INR 1.0], with rapid recovery on stopping and normal liver tests 6 weeks later).
Malhotra K, Fazylov R, Friedman-Jakubovics M. (2021). A case-report of drug-induced mixed liver injury resulting from cefepime exposure. J Pharm Pract. (99 year old man with urinary tract infection and sepsis developed liver test abnormalities within 2 days of starting iv cefepime and vancomycin, and peaked on day 4 [ALT ~210 U/L, AST ~240 U/L, Alk P 94 U/L, bilirubin normal], which returned to baseline within a 4 days of stopping cefepime).

## OTHER REFERENCE LINKS

1 Recent References on Cephalosporins: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=cephalosporins/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222007/3/01%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Cephalosporins: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=cephalosporins)